# Perampanel

## OVERVIEW

### Introduction

Perampanel is glutamate receptor antagonist that is used as an anticonvulsant in the therapy of partial onset seizures. Perampanel has not been associated with serum aminotransferase elevations during therapy, and clinically apparent liver injury from perampanel has yet to be reported and must be rare, if it occurs at all.

### Background

Perampanel (per am' pan el) is a glutamate receptor antagonist that is used to treat severe or refractory partial onset seizures. Perampanel binds to the alpha-amino-3-hydroxyl-5-methyl-4-isooxazole-propionate receptor (AMPAR) for glutamate, a major central nervous system excitatory neurotransmitter. The inhibition of the AMPAR leads to reduction in seizure activity in animal models as well as in patients with difficult to control seizures. In several large, prelicensure randomized controlled trials, addition of perampanel to conventional anticonvulsant medications led to improved control of epilepsy attributed to partial onset seizures. Perampanel was approved for use in the United States in 2012 as an anticonvulsant to be used in combination with other agents as adjunctive therapy of partial onset seizures. Perampanel is available in tablets of 4, 6, 8, 10 and 12 mg under the brand name Fycompa. The recommended initial dose is 2 mg once daily, which can be increased subsequently based upon tolerance and efficacy to a dose of 4 to 12 mg once daily. The dose should be increased and tapered gradually. The most common side effects include dizziness, somnolence, impaired concentration, vertigo, ataxia, nervousness, irritability, anger, aggression, blurred vision, headache, weight gain, fatigue, nausea and weakness. Rare, but potentially severe side effects include serious psychiatric and behavioral reactions including homicidal ideation and threats. Perampanel can cause euphoria for which reason it is classified as a scheduled III controlled substance, meaning that it has accepted medical uses, but also has a moderate or low potential for physical or psychological dependence.

### Hepatotoxicity

Limited data are available on the hepatotoxicity of perampanel. In clinical trials, therapy with perampanel was not associated with an increased frequency of serum aminotransferase elevations as compared to placebo treatment, and there were no reported instances of clinically apparent liver injury. No individual case reports of perampanel hepatotoxicity have been published since its general clinical availability. Perampanel has been implicated in rare instances of severe cutaneous hypersensitivity reactions including DRESS syndrome, which can be associated with variable degrees of liver injury. Thus, clinically apparent liver injury due to perampanel may occur, but must be very rare.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which perampanel might cause liver injury is unknown. It is partially metabolized by the liver, largely by CYP 3A4 and is susceptible to drug interactions with agents that induce or inhibit this microsomal enzyme.

### Outcome and Management

Liver injury from perampanel is rare, if it occurs at all. There is no reason to suspect cross sensitivity to hepatotoxicity between perampanel and other anticonvulsants such as phenytoin or carbamazepine with which it shares no structural similarity.

Drug Class: Anticonvulsants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Perampanel – Fycompa®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Perampanel)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Perampanel | 380917-97-5 | C23-H15-N3-O | Perampanel chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 04 May 2016

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999 before the availability of perampanel).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-42. (Review of anticonvulsant induced liver injury; perampanel is not discussed).
McNamara JO. Pharmacology of the epilepsies. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 583-607. (Textbook of pharmacology and therapeutics).
Krauss GL, Bar M, Biton V, Klapper JA, Rektor I, Vaiciene-Magistris N, Squillacote D, et al. Tolerability and safety of perampanel: two randomized dose-escalation studies. Acta Neurol Scand 2012; 125: 8-15. (Among 201 adults with refractory partial onset seizures enrolled in two studies of different doses of perampanel vs placebo for 6 to 7 weeks, there were no serious liver related adverse events and “no clinically significant differences” in laboratory values between placebo and perampanel treated subjects). 21883097
Rektor I, Krauss GL, Bar M, Biton V, Klapper JA, Vaiciene-Magistris N, Kuba R, et al. Perampanel Study 207: long-term open-label evaluation in patients with epilepsy. Acta Neurol Scand 2012; 126: 263-9. (Among 130 patients with refractory partial onset seizures who continued on perampanel after participation in controlled trials, 57 had at least 3 years and 18 had 4 years exposure; no new adverse events were uncovered, although one patient developed an ALT elevation above 5 times ULN at 2 years, but no details given). 22913800
French JA, Krauss GL, Biton V, Squillacote D, Yang H, Laurenza A, Kumar D, et al. Adjunctive perampanel for refractory partial-onset seizures: randomized phase III study 304. Neurology 2012; 79: 589-96. (Among 388 patients with refractory partial onset seizures treated with adjunctive perampanel [8 or 12 mg daily] or placebo for 19 weeks, serious adverse events occurred in 6.0 and 6.7% of perampanel vs 5.0% of placebo recipients, and there were no “clinically important mean changes in laboratory values”). 22843280
Hsu WW, Sing CW, He Y, Worsley AJ, Wong IC, Chan EW. Systematic review and meta-analysis of the efficacy and safety of perampanel in the treatment of partial-onset epilepsy. CNS Drugs 2013; 27: 817-27. (Systematic review of efficacy and safety of perampanel concludes that it resulted in a statistically significant decrease in seizure frequency and common side effects are dizziness and somnolence; no mention of ALT elevations or hepatotoxicity). 23918722
Steinhoff BJ, Ben-Menachem E, Ryvlin P, Shorvon S, Kramer L, Satlin A, Squillacote D, et al. Efficacy and safety of adjunctive perampanel for the treatment of refractory partial seizures: a pooled analysis of three phase III studies. Epilepsia 2013; 54: 1481-9. (Pooled analysis of results of three controlled trials of perampanel in patients with refractory partial onset seizures, mentions that there were no deaths and that serious adverse events occurred in 5.0% of placebo and 5.5% of perampanel recipients, none of which were liver related and that there were “no clinically important mean changes in laboratory values”). 23663001
French JA, Krauss GL, Steinhoff BJ, Squillacote D, Yang H, Kumar D, Laurenza A. Evaluation of adjunctive perampanel in patients with refractory partial-onset seizures: results of randomized global phase III study 305. Epilepsia 2013; 54: 117-25. (Among 386 patients with refractory partial onset seizures treated with perampanel [8 or 12 mg] or placebo for 19 weeks, the most common side effects were dizziness, somnolence, fatigue and headache, and there were no liver related serious adverse events and “no clinically important changes from baseline in mean laboratory values”). 22905857
Drugs for epilepsy. Treat Guidel Med Lett 2013; 11: 9-18. (Concise review of indications and side effects of anticonvulsants; perampanel is approved only as adjunctive treatment for partial onset seizures in patients 12 years old or older; no mention of adverse effects on the liver). 23348233
Gaitatzis A, Sander JW. The long-term safety of antiepileptic drugs. CNS Drugs 2013; 27 (6): 435-55. (Review of the adverse effects with long term anticonvulsant therapy including liver failure, nonalcoholic fatty liver, osteoporosis, skin and hair changes, reproductive health, cancer, heart, renal, lung, pancreas, gastrointestinal and psychiatric conditions; perampanel is mentioned, but not discussed). 23673774
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to perampanel). 23419359
Faulkner MA. Perampanel: a new agent for adjunctive treatment of partial seizures. Am J Health Syst Pharm 2014; 71: 191-8. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of perampanel does not mention any liver related serious adverse events and states that ALT and AST elevations above 3 times ULN occurred in fewer than 1% of recipients). 24429011
Krauss GL, Perucca E, Ben-Menachem E, Kwan P, Shih JJ, Clément JF, Wang X, et al. Long-term safety of perampanel and seizure outcomes in refractory partial-onset seizures and secondarily generalized seizures: results from phase III extension study 307. Epilepsia 2014; 55: 1058-68. (Summary of continued follow up on 1216 patients with refractory seizures who were enrolled in open label long term extension studies of perampanel including more than 300 followed for at least 2 years, ALT elevations above 3 times ULN occurred in less than 1% of patients; no specific mention of liver related serious adverse events). 24867391
Rugg-Gunn F. Adverse effects and safety profile of perampanel: a review of pooled data. Epilepsia. 2014 Jan; 55 Suppl 1: 13-5. (Review of adverse events reported in three controlled trials of perampanel mentions that there were “no clinically important changes” in biochemical parameters). 24400692
Perampanel (Fycompa) for epilepsy. Med Lett Drugs Ther 2014; 56 (1435): 9-10. (Concise review of the mechanism of action, clinical efficacy, adverse events, drug interactions, dosage and cost of perampanel shortly after its approval for use in epilepsy in the US does not mention hepatotoxicity or ALT elevations). 24662975
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were attributed to anticonvulsants, but none to perampanel). 25754159
Laurenza A, Yang H, Williams B, Zhou S, Ferry J. Absence of liver toxicity in perampanel-treated subjects: pooled results from partial seizure phase III perampanel clinical studies. Epilepsy Res 2015; 113: 76-85. (Among 1038 patients with refractory partial onset seizures treated with perampanel in 3 controlled trials, de novo ALT elevations occurred in 2.6% of placebo and 1.7% of perampanel treated subjects, and hepatobiliary adverse events occurred in only 4 perampanel and no placebo treated subjects which were cholelithiasis in 3 and transiently elevated liver tests without jaundice in 1 [<0.2%]). 25986193
Rosenfeld W, Conry J, Lagae L, Rozentals G, Yang H, Fain R, Williams B, et al. Efficacy and safety of perampanel in adolescent patients with drug-resistant partial seizures in three double-blind, placebo-controlled, phase III randomized clinical studies and a combined extension study. Eur J Paediatr Neurol 2015; 19: 435-45. (Summary of 3 controlled trials and an extension study of perampanel in 143 adolescents [ages 12-17] with refractory partial onset seizures, serious adverse events were rare, and none were liver related; there were “no clinically significant changes from baseline in clinical laboratory values”). 25823975
French JA, Krauss GL, Wechsler RT, Wang XF, DiVentura B, Brandt C, Trinka E, et al. Perampanel for tonic-clonic seizures in idiopathic generalized epilepsy: A randomized trial. Neurology 2015; 85: 950-7. (Among 164 patients with refractory tonic-clonic seizures treated with adjunctive perampanel or placebo for 17 weeks, there were no liver related serious adverse events and “no significant laboratory abnormalities”). 26296511

## OTHER REFERENCE LINKS

1. Recent References on Perampanel: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Perampanel+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Perampanel: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Perampanel)